# Atrasentan

## OVERVIEW

### Introduction

Atrasentan is a small molecule inhibitor of the endothelin type A receptor that is currently used to decrease proteinuria in patients with IgA nephropathy. Atrasentan is associated with a low rate of serum aminotransferase elevations during therapy but has not been implicated in cases of clinically apparent liver injury.

### Background

Atrasentan (a tra sen’ tan) is a small molecule inhibitor of the endothelin type A receptor that is used to reduce proteinuria in patients with progressive IgA nephropathy. Endothelin is a potent vasoconstrictor produced by endothelial cells that engages receptors on multiple different cells in liver, lung, kidney, brain and other tissues. Inhibitors of endothelin signaling are used in the therapy of hypertension, both essential arterial hypertension as well as pulmonary hypertension. Antagonism of endothelin receptors was proposed as possible therapy for IgA nephropathy based upon its additional pro-inflammatory, cell proliferation, and matrix stimulatory effects that can result in renal glomerular injury. IgA nephropathy is a common cause of chronic kidney disease and is marked by deposits of immune complexes with abnormal IgA molecules in glomeruli resulting in proteinuria, hypertension, and progressive renal dysfunction. The cause of IgA nephropathy is unknown, but it is believed to be immune mediated and is often treated with immunosuppressive agents, such as prednisone and budesonide which are only weakly effective and do not prevent longterm decline in kidney function. In animal models of IgA nephropathy, atrasentan decreased renal injury and fibrosis. In clinical trials in patients with IgA nephropathy, atrasentan therapy was associated with a greater mean decrease in the urine protein-to-creatinine ratio and resolution of proteinuria than occurred with placebo treatment. In 2025, atrasentan was given accelerated approval in the United States for use in adults with IgA nephropathy at high risk for progression. It is available in tablets of 0.75 mg under the brand name Vanrafia. The recommended dose is 0.75 mg (one tablet) once daily. Common side effects include peripheral edema, hypotension, dizziness, headache, rhinitis, hyperkalemia, and anemia. Atrasentan like other endothelin receptor antagonists causes embryo-fetal toxicity in animals and should not be used in pregnancy or in women of child-bearing potential not taking a reliable means of birth control.

### Hepatotoxicity

Liver test abnormalities are frequent in patients treated with endothelin receptor inhibitors but the rate and severity of the abnormalities varies with different antagonists. In pre-registration placebo controlled trials of atrasentan, mild to moderate elevations in serum aminotransferase levels occurred in 4.5% of treated patients compared to 0.5% given placebo. The liver test abnormalities were transient and asymptomatic, and no patient developed symptoms or jaundice. The elevations typically occurred during the first 2 to 3 months of therapy and resolved without dose modification or discontinuation. In trials of atrasentan in other forms of chronic kidney disease (diabetic nephropathy), similar low rates of liver enzyme elevations arose and there were no cases of clinically apparent liver injury with jaundice. Indeed, in previous studies of atrasentan as therapy of cancer with markedly higher doses, no cases of clinically apparent hepatic injury were reported. Clinical experience with atrasentan as therapy of IgA nephropathy has been limited, but ongoing trials have supported its safety.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which atrasentan causes serum aminotransferase elevations is not known. Atrasentan has been implicated in rare instances of hypersensitivity (urticaria), and mild and transient immune-mediated hepatic injury followed by “adaptation” may account for the liver test abnormalities identified in prospective studies. Atrasentan is metabolized in the liver, largely by CYP 3A4 and coadministration of agents that induce this enzyme (such as rifamin) may lower plasma levels causing lack of potency and agents that strongly inhibit CYP 3A4 may result in higher drug levels causing an increase in adverse effects. Atrasentan is transported by OATP1B1/1B3, and coadministration to inhibitors of the transporter (such as cyclosporin) may cause increases in plasma levels of atrasentan and increased risk of adverse events.

### Outcome and Management

The serum aminotransferase elevations that occur on atrasentan therapy are usually self-limited and do not require dose modification or discontinuation of therapy. However, persistent ALT or AST elevations above 3 times the upper limit of the normal range (ULN) should lead to dose adjustment or discontinuation. Any ALT elevation above 10 times the ULN or ALT elevations with symptoms or jaundice should lead to immediate discontinuation. There is no information on possible cross-sensitivity to liver damage with other endothelin receptor antagonists, such as sparsentan.

Drug Class: Renal Disease Agents Endothelin Receptor Antagonists

Other Drugs in the Subclass: Sparsentan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atrasentan – Vanrafia®

DRUG CLASS

Renal Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Atrasentan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Atrasentan | 173937-91-2 | C29-H38-N2-O6

ANNOTATED BIBLIOGRAPHY

References updated: January 6, 2026

Abbreviations: IgA, immunoglobulin A; ULN, upper limit of the normal range.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of published in 1999; before the availability of endothelin receptor antagonists).
Fraidenburg DR, Desai AA, Yuan JX-J. Endothelin and endothelin receptor antagonists. Treatment of pulmonary arterial hypertension. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 579-580. (Textbook of pharmacology and therapeutics).
FDA: 2023. Integrated review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/219208Orig1s000TOC.cfm (FDA website with product label and integrated review of the safety and efficacy of atrasentan provided by the drug sponsor in support of its approval for therapy of IgA nephropathy in the United States, mentions that in registration trials, there were no serious hepatic adverse events, and that ALT or AST elevations above 3 times upper limit of normal [ULN] arose in 2.5% of atrasentan vs 0.5% placebo recipients, that elevations arose during the first few months of treatment, were self-limited in course, and not accompanied by symptoms or jaundice).
Carducci MA, Nelson JB, Bowling MK, Rogers T, Eisenberger MA, Sinibaldi V, Donehower R, et al. Atrasentan, an endothelin-receptor antagonist for refractory adenocarcinomas: safety and pharmacokinetics. J Clin Oncol. 2002;20:2171-80.. (Among 31 adults with adenocarcinoma treated with atrasentan in oral doses of 10 to 75 mg daily for 28 days, common adverse events included rhinitis, headache, fatigue, and peripheral edema; no mention of hepatic adverse events and “serum hepatic transaminase and creatinine values did not increase significantly” ). 11956279
Carducci MA, Saad F, Abrahamsson PA, Dearnaley DP, Schulman CC, North SA, Sleep DJ, et al; Atrasentan Phase III Study Group Institutions. A phase 3 randomized controlled trial of the efficacy and safety of atrasentan in men with metastatic hormone-refractory prostate cancer. Cancer. 2007;110:1959-66.. (Among 809 men with metastatic prostate cancer treated with atrasentan [10 mg] or placebo once daily, treatment had no effect on disease progression but was “generally well tolerated” with serious adverse events arising in 29% vs 26%; no mention of hepatic adverse events or ALT elevations) 17886253
Kohan DE, Barton M. Endothelin and endothelin antagonists in chronic kidney disease. Kidney Int. 2014;86:896-904.. (Review of the synthesis, distribution, pharmacology and activity of the endothelin system and the potential role of its inhibition in treatment of chronic kidney disease). 24805108
Heerspink HJL, Parving HH, Andress DL, Bakris G, Correa-Rotter R, Hou FF, Kitzman DW, et al.; SONAR Committees and Investigators. Atrasentan and renal events in patients with type 2 diabetes and chronic kidney disease (SONAR): a double-blind, randomised, placebo-controlled trial. Lancet. 2019;393:1937-1947.. (Among 2648 patients with diabetes and chronic renal disease treated with atrasentan [0.75 mg] or placebo once daily for a median of 2.2 years, renal events were less with atrasentan [6.0% vs 7.9%] but serious adverse events were more frequent [36% vs 33%] none of which were reported as hepatic related; no mention of ALT elevations or hepatotoxicity). 30995972
Benigni A, Buelli S, Kohan DE. Endothelin-targeted new treatments for proteinuria and inflammatory glomerular diseases: focus on the added value to anti-renin-angiotensin system inhibition. Pediatr Nephrol. 2021;36:763-775.. (Review of the role of endothelin in normal renal physiology as well as in causing progression in chronic renal disease and the effects of endothelin receptor inhibition in improving renal function and decreasing fibrosis in animal models of chronic kidney disease and having antiproteinuric effects in human diseases). 32185491
Kohan DE, Liew A, Tang SCW, Barratt J, Heerspink HJL. Effects of atrasentan on markers of liver function in patients with type 2 diabetes and chronic kidney disease. Diabetes Obes Metab. 2023;25:2410-2412.. (Among 3668 patients with diabetes and chronic kidney disease treated with atrasentan [0.75 mg] vs placebo [Heerspink 2019], liver test abnormalities arose in 3.1% vs 2.9%, but none were associated with jaundice, and overall the mean ALT and AST levels decreased slightly on atrasentan therapy). 37139863
Heerspink HJL, Jardine M, Kohan DE, Lafayette RA, Levin A, Liew A, Zhang H, et al.; ALIGN Study Investigators. Atrasentan in patients with iga nephropathy. N Engl J Med. 2025;392:544-554.. (Among 270 patients with IgA nephropathy treated with atrasentan [0.75 mg] vs placebo once daily for 36 weeks, decreases in urinary protein to creatinine ratio decreased by -38% vs -3% while adverse event rates were similar in both groups [82% vs 85%] including serious adverse events [5.9% vs 6.5%] none of which were liver related; no mention of ALT elevations or hepatotoxicity). 39460694
Smeijer JD, Kohan DE, Dhaun N, Noronha IL, Liew A, Heerspink HJL. Endothelin receptor antagonists in chronic kidney disease. Nat Rev Nephrol. 2025;21:175-188.. (Extensive review of the role of endothelin receptor antagonists in the treatment of chronic kidney diseases mentions that liver toxicity has been observed with some endothelin receptor antagonists, particularly bosentan, but for most, including atrasentan, liver enzyme elevations have been modest). 39643698

## OTHER REFERENCE LINKS

1. Recent References on Atrasentan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Atrasentan/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Atrasentan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Atrasentan)